# Isradipine

## OVERVIEW

### Introduction

Isradipine is a second generation calcium channel blocker that is used to treat hypertension. Isradipine is associated with a low rate of serum enzyme elevations during therapy, but has not been linked convincingly to instances of clinically apparent liver injury.

### Background

Isradipine (is rad' i peen) is an antihypertensive medication that belongs to the dihydropyridine class of calcium channel blockers. Like other calcium channel blockers, isradipine acts by blocking the influx of calcium ions into smooth muscle and cardiac cells using depolarization. This inhibition leads to vasodilation and decrease in cardiac work and oxygen consumption. Isradipine was approved in the United States in 1990 and its current sole indication is for hypertension. Isradipine is available in extended release capsules of 2.5, 5 and 10 mg generically and formerly under the commercial name DynaCirc. The recommended dose in adults is 5 to 10 mg in one or two divided doses daily. Like other calcium channel blockers, isradipine is generally well tolerated. Side effects are largely due to its vasodilating activities and include headache, dizziness, flushing, fatigue, nausea, peripheral edema and rash.

### Hepatotoxicity, Outcome and Management

Isradipine is reported to be associated with mild elevations in serum aminotransferase levels during therapy that are usually transient, asymptomatic and resolve even with continued therapy. Cases of idiosyncratic liver injury attributed to isradipine have not been published. Large trials of isradipine have not mentioned liver injury, persistent serum aminotransferase elevations or discontinuation of drug because of hepatic adverse events. Liver injury has been reported with other calcium channel blockers such as verapamil, diltiazem, amlodipine and nifedipine, but only as isolated case reports and the injury was generally mild and self-limiting in outcome. Thus, clinically apparent liver injury due to isradipine must be rare, if it occurs at all.

Likelihood score: E (Unlikely cause of clinically apparent liver injury).

The reason why some calcium channel blockers are associated with liver injury while others are not is unclear. Isradipine is metabolized by the hepatic P450 system, predominantly by CYP 3A4 and is susceptible to drug-drug interactions with agents that induce or inhibit the microsomal enzyme.

Drug Class: Cardiovascular Agents, Calcium Channel Blockers

Other Drugs in the Subclass, Calcium Channel Blockers: Amlodipine, Diltiazem, Felodipine, Nicardipine, Nifedipine, Nimodipine, Nisoldipine, Verapamil

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Isradipine – Generic, DynaCirc®

DRUG CLASS

Cardiovascular Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=isradipine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Isradipine | 75695-93-1 | C19-H21-N3-O5 | Isradipine chemical structure

## ANNOTATED BIBLIOGRAPHY

References updated: 11 January 2017

Zimmerman HJ. Calcium channel blockers. Drugs used in cardiovascular disease. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 646-7. (Expert review of hepatotoxicity published in 1999; among calcium channel blockers, diltiazem, nifedipine, bepridil and verapamil have been incriminated in instances of hepatic injury; isradipine is not mentioned).
De Marzio DH, Navarro VJ. Calcium channel blockers. Hepatotoxicity of cardiovascular and antidiabeticdrugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 524. (Review of hepatotoxicity published in 2013; diltiazem, nifedipine and verapamil have been implicated as the cause of liver injury in a small number of patients; isradipine is not specifically mentioned).
Michel T, Hoffman BB. Calcium channel blockers. Treatment of myocardial ischemia and hypertension. In, Brunton LL, Chabner KA, Knollman KC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 766-7. (Textbook of pharmacology and therapeutics).
Nelson EB, Pool JL, Taylor AA. Antihypertensive activity of isradipine in humans: a new dihydropyridine calcium channel antagonist. Clin Pharmacol Ther 1986; 40: 694-7. (Controlled trial of isradipine in 24 patients with hypertension for 3 weeks; there were no significant changes in ALT or AST values during treatment). 2946507
Shepherd AM, Carr AA, Davidov M, Hamilton J, Schnaper H, Velasquez M, Brockway B, Prisant LM, et al. Efficacy and safety of isradipine in hypertension. J Cardiovasc Pharmacol 1989; 13: 580-5. (Among 203 patients with hypertension given placebo or one of 5 doses of isradipine for 5 weeks, adverse effects were mild; 19 on isradipine [11%] and 4 on placebo [10%] had an elevation of at least one liver test, but most were transient and asymptomatic). 2470995
British Isradipine Hypertension Group. Evaluation of the safety and efficacy of isradipine in elderly patients with essential hypertension. Am J Med 1989; 86: 110-4. (Among 118 elderly patients with hypertension treated with placebo or two doses of isradipine for up to 4 years, there were no differences in biochemical abnormalities between the placebo- and isradipine-treated groups). 2523644
Dahlöf B. Hemodynamic response, safety, and efficacy of isradipine in the treatment of essential hypertension. Am J Med 1989; 86 (4A): 19-26. (Among 1028 patients with hypertension treated with one of 6 different doses of isradipine in 15 different studies, side effects were more frequent at higher doses and included low rates of headache, flushing, dizziness, palpitations and peripheral edema; in one studfy of 288 patients, liver test abnormalities occurred in 6.3%). 2523651
Sundstedt CD, Rüegg PC, Keller A, Waite R. A multicenter evaluation of the safety, tolerability, and efficacy of isradipine in the treatment of essential hypertension. Am J Med 1989; 86(4A): 98-102. (Among 600 patients with hypertension treated with one of 3 doses of isradipine or placebo, common side effects were flushing [10.5%], headache [10.2%], and peripheral edema [4.2%]; 4 patients [0.6%] had serum aminotransferase elevations, but most were considered unrelated and all were mild, asymptomatic and did not require dose adjustment). 2523665
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl 2004; 10: 1018-23. (Among ~50,000 liver transplants reported to UNOS between 1990 and 2002, 270 [0.5%] were done for drug induced acute liver failure, but none were attributed to a calcium channel blocker). 15390328
Björnsson E, Jerlstad P, Bergqvist A, Olsson R. Fulminant drug-induced hepatic failure leading to death or liver transplantation in Sweden. Scand J Gastroenterol 2005; 40: 1095-101. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/16165719) (Summary of 25 years of adverse drug reaction reporting in Sweden identified 103 cases of drug induced acute liver failure; only one case was possibly linked to a calcium channel blocker: felodipine).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/18955056) (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, calcium channel blockers were implicated as a sole agent in 2 cases [1 amlodipine, 1 verapamil] and as one of several agents in 2 cases [both amlodipine]).
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, none of which were attributed to isradipine or other calcium channel blockers). 20949552
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, none of which was attributed to a calcium channel blocker or other antihypertensive medication). 23419359
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases; one case was attributed to verapamil, but none were linked to isradipine or other calcium channel blockers). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 39 [4%] were due to antihypertensive agents including 4 due to calcium channel blockers [amlodipine in 1 and verapamil in 3 instances], but none to isradipine). 25754159

## OTHER REFERENCE LINKS

1. Recent References on Isradipine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=isradipine/AE+AND+Human%5BMH%5D+AND+(%20drug-induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Isradipine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=isradipine)